# Antidiabetic Agents

## OVERVIEW

Management and treatment of diabetes usually begins with advice on diet and exercise. Insulin is the therapeutic mainstay of therapy of type 1 diabetes, whereas agents that increase insulin secretion or activity are the primary approaches to therapy of type 2 diabetes. First line conventional therapies for type 2 diabetes include biguanides (metformin) and sulfonylureas. Metformin increases insulin sensitivity whereas the sulfonylureas increase insulin secretion. More recently developed agents include alpha glucosidase inhibitors, thiazolidinediones, metiglidine analogues and drugs that affect the incretin system. Alpha glucosidase inhibitors act in the gastrointestinal tract to decrease glucose absorption. The thiazolidinediones affect multiple intracellular metabolic pathways that increase insulin actions and improve insulin sensitivity. Metiglidines, like the sulfonylureas, increase insulin secretion. Finally, drugs that affect the incretin system include analogues of glucagon-like peptide-1 (GLP-1) that promote early insulin release from the pancreas and inhibitors of dipeptiyl peptidases 4 (DPP-4) that prolong the activity of GLP-1 in the serum. A relatively new category of antidiabetic agents are inhibitors of the sodium glucose cotransporter-2 (SGLT2), which is responsible for reabsorption of glucose in the kidney; inhibition of this transporter causes glucosuria and can reduce hyperglycemia in patients with diabetes. The first commercially available SGLT2 inhibitors (canagliflozin and dapagliflozin) were approved for use in the United States in 2013. Most antidiabetic agents have minimal adverse effects on the liver and have only rarely been linked to instances of clinically apparent acute liver injury.

- Alpha-Glucosidase Inhibitors
  - Acarbose
  - Miglitol
- Incretin-Based Drugs
  - Dipeptidyl Peptidase-4 (DPP-4) Inhibitors
    - Alogliptin
    - Linagliptin
    - Saxagliptin
    - Sitagliptin
  - Glucagon-Like Peptide-1 (GLP-1) Analogues
    - Albiglutide
    - Dulaglutide
    - Exenatide
    - Liraglutide
    - Lixisenatide
    - Semaglutide
    - Tirzepatide
- Insulin
- Metformin
- Metiglinide Analogues
  - Nateglinide
  - Repaglinide
- Pramlintide
- Sodium Glucose Cotransporter-2 (SGLT2) Inhibitors
  - Bexagliflozin
  - Canagliflozin
  - Dapagliflozin
  - Empagliflozin
  - Ertugliflozin
- Sulfonylureas
  - First Generation Sulfonylureas
    - Acetohexamide
    - Chlorpropamide
    - Tolazamide
    - Tolbutamide
  - Second Generation Sulfonylureas
    - Gliclazide
    - Glimepiride
    - Glipizide
    - Glyburide (Glibenclamide)
- Thiazolidinediones
  - Pioglitazone
  - Rosiglitazone
  - Troglitazone
- Miscellaneous
  - Teplizumab

Updated: February 22, 2023

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2017

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999, discusses hepatotoxicity of sulfonylureas, thiazolidinediones, acarbose and metformin).
De Marzio DH, Navarro VJ. Alpha-glucosidase inhibitors. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 529-30. (Recent review of hepatotoxicity of drugs for diabetes).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1248-67. (Textbook of pharmacology and therapeutics).
Davis SN. Insulin, oral hypoglycemic agents, and the pharmacology of the endocrine pancreas. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1613-88. (Textbook of pharmacology and therapeutics).
(2014). Drugs for type 2 diabetes. Treat Guidel Med Lett. (Concise review of current therapy of type 2 diabetes).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 4 cases were attributed to drugs used for diabetes [metformin, glyburide, sitagliptin], but no cases were attributed to acarbose or a thiazolidinedione).
(2017). Drugs for type 2 diabetes. Med Lett Drugs Ther. (Concise summary of the mechanisms of action, efficacy, safety and costs of currently available drugs for type 2 diabetes; mentions that serum enzyme elevations can occur with acarabose therapy and that hepatitis and liver failure have been described with thiazolidinedione and DDP-4 inhibitor therapy).